# Vemurafenib

## OVERVIEW

### Introduction

Vemurafenib is a selective inhibitor of BRAF kinase that is used in the therapy of patients with metastatic and advanced malignant melanoma. Vemurafenib therapy is commonly associated with transient elevations in serum aminotransferase during therapy and has been linked to rare, but occasionally severe cases of clinically apparent acute liver injury.

### Background

Vemurafenib (vem’ ue raf” e nib) is an orally available inhibitor of mutated forms of BRAF, a serine/threonine kinase that is a component of the mitogen-activated pathway (MAP) kinases which are important intracellular signals involved in control of cell growth and proliferation. BRAF kinase is an early step in the cascade of MAP kinases (RAS-RAF-MEK-ERK) and is frequently mutated in malignant conditions, including at least half of cases of melanoma. Vemurafenib was shown to be active against the V600E mutants of BRAF in vitro and in animal models. Furthermore, in clinical trials vemurafenib therapy was associated with an improvement in overall survival in patients with metastatic malignant melanoma with V600E mutations. Vemurafenib was approved for use in the United States in 2011 and current indications are for unresectable or metastatic melanoma with the BRAF V600E mutation and Langerhans-cell histiocytosis with BRAF V600 mutations. Vemurafenib is available in tablets of 240 mg under the brand name Zelboraf. The typical dose is 960 mg (4 tablets) twice daily. Common side effects include fatigue, nausea, arthralgias, rash, alopecia, photosensitivity, pruritus, and skin papilloma. Uncommon, but potentially severe side effects include severe skin and hypersensitivity reactions (including Stevens Johnson syndrome), cutaneous squamous cell carcinoma, ocular toxicity, and prolonged QTc intervals.

### Hepatotoxicity

In large clinical trials of vemurafenib, abnormalities in routine liver tests were common and serum aminotransferase elevations occurred in up to one third of patients. ALT and AST values greater than 5 times the upper limit of normal (ULN) occurred in 3% of patients, and rare instances of clinically apparent liver injury were reported, but the clinical features of the injury have not been described. The onset of liver test abnormalities was typically within 3 to 6 weeks of starting vemurafenib, and the abnormalities resolved rapidly either spontaneously or with temporary drug discontinuation. Vermurafenib has also been linked to instances of drug related rash with eosinophilia and systemic manifestations (DRESS) as well as Stevens Johnson syndrome, both of which can be accompanied by liver dysfunction and in some cases jaundice with clinically apparent liver injury.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury.

### Mechanism of Injury

The mechanism of injury accounting for serum enzyme elevations during vemurafenib therapy is not known. Vemurafenib is metabolized in the liver largely through the CYP 1A2 pathway and liver injury may be related to production of a toxic intermediate. The rare cases of liver injury accompanying severe skin reactions are likely related to hypersensitivity. Vemurafenib is susceptible to drug-drug interactions with agents that inhibit or induce hepatic CYP 1A2 activity.

### Outcome and Management

In using kinase inhibitors in the therapy of cancer, monitoring of routine liver tests before starting and during therapy is warranted. Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) or any elevations accompanied by jaundice or symptoms should lead to temporary cessation. Restarting vemurafenib after temporary cessation should be done with caution and only after the liver test abnormalities have resolved or improved significantly. There does not appear to be cross reactivity in risk for hepatic injury between vemurafenib and other kinase inhibitors and, in some situations, switching to another BRAF inhibitor may be appropriate.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Vemurafenib – Zelboraf®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Vemurafenib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Vemurafenib | 918504-65-1 | C23-H18 Cl-F2-N3-O3-S | Vemurafenib chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 28 June 2018

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of kinase inhibitors such as vemurafenib).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses several kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not vemurafenib).
Chabner BA, Barnes J, Neal J, Olson E, Mujagic H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-54. (Textbook of pharmacology and therapeutics).
Flaherty KT, Puzanov I, Kim KB, Ribas A, McArthur GA, Sosman JA, O'Dwyer PJ, Lee RJ, et al. Inhibition of mutated, activated BRAF in metastatic melanoma. N Engl J Med 2010; 363: 809-19. (Among 87 patients with metastatic melanoma treated with escalating doses of vemurafenib, objective responses occurred at doses at or above 240 mg twice daily in patients with the BRAF V600E mutation, and adverse events included squamous cell carcinoma [21%], arthralgias, rash, nausea, photosensitivity and fatigue; no mention of ALT elevations or hepatotoxicity). 20818844
Vemurafenib (Zelboraf) for metastatic melanoma. Med Lett Drugs Ther 2011; 53 (1374): 77-8. (Concise description of mechanism of action, efficacy, safety and costs of vemurafenib for metastatic melanoma, does not mention ALT elevations or hepatotoxicity, but does mention Stevens Johnson syndrome, toxic epidermal necrolysis and anaphylaxis). 21959356
Chapman PB, Hauschild A, Robert C, Haanen JB, Ascierto P, Larkin J, Dummer R, et al.; BRIM-3 Study Group. Improved survival with vemurafenib in melanoma with BRAF V600E mutation. N Engl J Med 2011; 364: 2507-16. (Among 675 patients with metastatic melanoma and the BRAF V600E mutation, overall survival was greater with vemurafenib than dacarbazine treatment [84% vs 64% at 6 months], and the most common adverse events were skin toxicity, arthralgias and fatigue; Alk P elevations occurred in 7% of vemurafenib treated patients; rates of ALT elevations and hepatotoxicity were not provided). 21639808
Sosman JA, Kim KB, Schuchter L, Gonzalez R, Pavlick AC, Weber JS, McArthur GA, et al. Survival in BRAF V600-mutant advanced melanoma treated with vemurafenib. N Engl J Med 2012; 366: 707-14. (Among 132 patients with advanced melanoma with BRAF V600 mutations and previous treatment treated with vemurafenib, confirmed responses occurred in 53% and common side effects included arthralgia, rash, photosensitivity and fatigue, and elevated liver enzymes were reported in 17% of patients and were severe in 4 [3%] which led to drug discontinuation in some, but did not result in deaths). 22356324
Wenk KS, Pichard DC, Nasabzadeh T, Jang S, Venna SS. Vemurafenib-induced DRESS. JAMA Dermatol 2013; 149: 1242-3. (80 year old woman with melanoma developed generalized fever and skin rash 3 weeks after starting vemurafenib [eosinophils 26%, ALT 132 U/L, bilirubin and Alk P not given], resolving within 6 weeks on corticosteroids). 23986488
Tsai KY, Nowroozi S, Kim KB. Drug safety evaluation of vemurafenib in the treatment of melanoma. Expert Opin Drug Saf 2013; 12: 767-75. (Review of safety of vemurafenib focusing on skin toxicity and secondary malignancies, mentions that grade 3 liver test abnormalities are reported in 0-6% of treated patients). 23800008
Anker CJ, Ribas A, Grossmann AH, Chen X, Narra KK, Akerley W, Andtbacka RH, et al. Severe liver and skin toxicity after radiation and vemurafenib in metastatic melanoma. J Clin Oncol 2013; 31: e283-7. (15 year old girl with melanoma metastatic to brain, bone and liver developed fatal intrahepatic hemorrhage after vemurafenib and radiation therapy, and was found to have melanoma lined cysts with hemorrhage and acute hepatic necrosis on autopsy). 23650406
Ribas A, Hodi FS, Callahan M, Konto C, Wolchok J. Hepatotoxicity with combination of vemurafenib and ipilimumab. N Engl J Med 2013; 368: 1365-6. (In a pilot study of the combination of vemurafenib and ipilimumab in 10 patients with metastatic melanoma, serum ALT or AST elevations ≥5 times ULN arose within 13-36 days of starting therapy in 6 patients, all of which were asymptomatic and reversible, which resolved within 4-12 days with corticosteroid therapy, recurring in one patient on restarting ipilimumab). 23550685
da Rocha Dias S, Salmonson T, van Zwieten-Boot B, Jonsson B, Marchetti S, Schellens JH, Giuliani R, et al. The European Medicines Agency review of vemurafenib(Zelboraf®) for the treatment of adult patients with BRAF V600 mutation-positive unresectable or metastatic melanoma with BRAF V600 mutations: summary of the scientific assessment of the Committee for Medicinal Products for Human Use. Eur J Cancer 2013; 49: 1654-61. (Report of regulatory review of vemurafenib including data on clinical safety in 866 patients, mentions one case of Stevens Johnson syndrome and that liver test abnormalities occurred in 18% of patients, usually arising after 3-6 weeks and usually mild [< grade 3]). 23481513
Muluneh B, Buie LW, Collichio F. Vemurafenib-associated pancreatitis: case report. Pharmacotherapy 2013; 33: e43-4. (49 year old man developed epigastric pain 2 weeks after starting vemurafenib for metastatic melanoma [lipase 1544 U/L, no other laboratory results provided], which resolved upon stopping and recurred within two days of restarting vemurafenib). 23436544
Degen A, Völker B, Kapp A, Gutzmer R. Erythema nodosum in a patient undergoing vemurafenib therapy for metastatic melanoma. Eur J Dermatol 2013; 23: 118. 23419281
Spraggs CF, Xu CF, Hunt CM. Genetic characterization to improve interpretation and clinical management of hepatotoxicity caused by tyrosine kinase inhibitors. Pharmacogenomics 2013; 14: 541-54. (Review of genetic associations of serum ALT and bilirubin elevations during therapy with tyrosine kinase inhibitors, focusing on lapatinib and pazopanib). 23556451
Shah RR, Morganroth J, Shah DR. Hepatotoxicity of tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf 2013; 36: 491-503. (Review of the hepatotoxicity of 18 tyrosine kinase inhibitors approved for use in cancer in the US as of 2013; aminotransferase elevations occurred in 35-38% of patients in registration trials of vemurafenib, were above 5 times ULN in 3% and cases of clinically apparent liver injury, but not hepatic failure, have been reported). 23620168
Larkin J, Del Vecchio M, Ascierto PA, Krajsova I, Schachter J, Neyns B, Espinosa E, et al. Vemurafenib in patients with BRAF (V600) mutated metastatic melanoma: an open-label, multicentre, safety study. Lancet Oncol 2014; 15: 436-44. (Among 3222 patients with metastatic melanoma with BRAF V600 mutations enrolled in an open label safety study of vemurafenib, liver test abnormalities arose in 13% [≥grade 3 in 5%], including ALT elevations in 2.9% [≥5 times ULN in 1.6%] and Alk P elevations in 3.1% [≥3 times ULN in 1.1%], but no deaths were attributed to hepatic failure). 24582505
McArthur GA, Chapman PB, Robert C, Larkin J, Haanen JB, Dummer R, Ribas A, et al. Safety and efficacy of vemurafenib in BRAF (V600E) and BRAF (V600K) mutation-positive melanoma (BRIM-3): extended follow-up of a phase 3, randomised, open-label study. Lancet Oncol 2014; 15: 323-32. (Among 675 patients with metastatic melanoma with BRAF V600 mutations, median overall survival was longer in those treated with vemurafenib than dacarbazine [36.5 vs 9.7 months], and 31% on vemurafenib developed abnormal liver tests [which were ≥grade 3 in 11%] compared to 6% [with 2% ≥grade 3] on dacarbazine). 24508103
Hyman DM, Puzanov I, Subbiah V, Faris JE, Chau I, Blay JY, Wolf J, et al. Vemurafenib in Multiple nonmelanoma cancers with BRAF V600 mutations. N Engl J Med 2015; 373: 726-36. (Among 122 patients with various non-melanoma cancers with BRAF-V600 mutation treated with vemurafenib, the overall response rate was 42% with best results in Langerhans-cell histiocytosis and adverse events were frequent including rash [68%], fatigue [56%] and arthralgia [40%]; no mention or listing for ALT elevations or hepatotoxicity). 26287849
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 [6%] were attributed to antineoplastic agents including 9 to kinase inhibitors including imatinib, lapatinib and regorafinib but not vemurafenib). 25754159
Arance AM, Berrocal A, Lopez-Martin JA, de la Cruz-Merino L, Soriano V, Martín Algarra S, Alonso L, et al. Safety of vemurafenib in patients with BRAF (V600) mutated metastatic melanoma: the Spanish experience. Clin Transl Oncol 2016; 18: 1147-57. (Among 301 Spanish patients with metastatic melanoma and BRAF-V600 mutations treated with vemurafenib, the overal response rate was 28% and adverse events were frequent [99%] including "liver function abnormalities" in 11% which were above 5 times ULN in 5%, but there were no liver related severe adverse events or deaths). 26983408
Ascierto PA, McArthur GA, Dréno B, Atkinson V, Liszkay G, Di Giacomo AM, Mandalà M, et al. Cobimetinib combined with vemurafenib in advanced BRAF(V600)-mutant melanoma (coBRIM): updated efficacy results from a randomised, double-blind,phase 3 trial. Lancet Oncol 2016; 17: 1248-60. (Among 495 patients with advanced melanoma and BRAF-V600 mutations treated with vemurafenib with or without cobimetinib, progression free survival was better with the combination [12 vs 7 months] as were severe adverse events [37% vs 28%] including photosensitivity [34% vs 20%], serous retinopathy [27% vs 4%], left ventricular dysfunction [11% vs 5%] and discontinuations for liver test abnormalities [2% vs <1%], but no deaths were attributed to liver failure). 27480103
Blank CU, Larkin J, Arance AM, Hauschild A, Queirolo P, Del Vecchio M, Ascierto PA, et al. Open-label, multicentre safety study of vemurafenib in 3219 patients with BRAF (V600) mutation-positive metastatic melanoma: 2-year follow-up data and long-term responders' analysis. Eur J Cancer 2017; 79: 176-84. (Among 3219 patients with advanced melanoma and BRAF-V600 mutations treated with vemurafenib in an open label safety study with median follow up of 32 months, adverse events were frequent including arthralgia [37%], alopecia [25%], squamous cell skin cancer [8%] while hepatotoxicity was reported in only 8 patients [0.2%], drug induced liver injury in 3 [<0.1%] and liver failure in 1 [<0.1%]). 28501764
Uhara H, Kiyohara Y, Tsuda A, Takata M, Yamazaki N. Characteristics of adverse drug reactions in a vemurafenib early post-marketing phase vigilance study in Japan. Clin Transl Oncol 2018; 20: 169-75. (Among 95 Japanese patients with metastatic melanoma treated with vemurafenib in a postmarketing study, adverse events included "hepatic function abnormal" in 2, both of which were "non-serious"; 13 subjects developed serious adverse events, none of which were liver related but 7 were skin reactions including one case of Stevens Johnson syndrome). 28674996
Chapman PB, Robert C, Larkin J, Haanen JB, Ribas A, Hogg D, Hamid O, et al. Vemurafenib in patients with BRAFV600 mutation-positive metastatic melanoma: final overall survival results of the randomized BRIM-3 study. Ann Oncol 2017; 28: 2581-7. (Among 675 patients with metastatic melanoma and BRAF- V600 mutations treated with vemurafenib or dacarbazine, median overall survival was longer for vemurafenib [14 vs 10 months] and adverse events included one case of acute hepatitis and one of Stevens Johnson syndrome, but details were not provided). 28961848
Diamond EL, Subbiah V, Lockhart AC, Blay JY, Puzanov I, Chau I, Raje NS, et al. Vemurafenib for BRAF V600-mutant Erdheim-Chester Disease and Langerhans cell histiocytosis: analysis of data from the histology-independent, phase 2, open-label VE-BASKET Study. JAMA Oncol 2018; 4: 384-8. (Among 26 patients with Langerhans-cell histiocytosis treated with vemurafenib, the overall response rate was 62% and overall survival was 96% at two years; adverse events arose in all patients and led to dicontinuation in 8 [31%]; ALT elevations and hepatotoxicity not listed among adverse events occurring in at least 20% of patients). 29188284
Bunchorntavakul C, Reddy KR. Drug hepatotoxicity: newer agents. Clin Liver Dis 2017; 21: 115-34. (Review of the hepatotoxicity of recently approved medications including the tyrosine kinase inhibitors, including vemurafenib which has been linked to a high rate of ALT elevations [35-38%] and to cases of severe [but not fatal] hepatotoxicity typically within 3 to 6 months of starting therapy). 27842767

## OTHER REFERENCE LINKS

1. Recent References on Vemurafenib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Vemurafenib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Vemurafenib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Vemurafenib)